# Inotuzumab Ozogamicin

## OVERVIEW

### Introduction

Inotuzumab ozogamicin is a humanized monoclonal antibody-cytotoxin conjugate which is used in the therapy of refractory or relapsed acute lymphoblastic leukemia. Inotuzumab ozogamicin has been linked to frequent serum enzyme elevations during therapy and with instances of clinically apparent acute liver injury, including acute sinusoidal obstruction syndrome which can be severe and even fatal.

### Background

Inotuzumab (in" oh tooz' ue mab) ozogamicin (oh" zoe ga mye' sin) is a humanized monoclonal antibody conjugate that is used in the therapy of B-cell precursor acute lymphoblastic leukemia. The monoclonal antibody is to the human CD22 cell surface marker which is highly expressed on malignant lymphoblastic leukemia cells. The monoclonal antibody is conjugated to a cytotoxic agent from a class of calicheamicins called ozogamicin. When inotuzumab binds to CD22, it is internalized and the ozogamicin is released by the action of lysosomal enzymes on the linker molecule that joins it to the monoclonal antibody. The released intracellular ozogamicin causes breaks in double stranded DNA that leads to apoptotic cell death. This monoclonal antibody conjugate has been shown to be effective in inducing remissions in relapsed or refractory B-cell precursor acute lymphoblastic leukemia and was given accelerated approval for this indication in the United States in 2017. Inotuzumab ozogamicin is available as 0.9 mg of lyophilized powder in single dose vials for reconstitution under the brand name Besponsa. The recommended dose regimen varies by body weight, day of therapy and whether treating refractory vs relapsed acute lymphoblastic leukemia. Inotuzumab ozogamicin is given intravenously typically on days 1, 8 and 15 of 21- or 28-day cycles. Premedication with a corticosteroid, antipyretic, and antihistamine is recommended before each dose. Common side effects include bone marrow suppression, infections, fatigue, fever, nausea, headache, abdominal pain and hemorrhage. Less common but potentially serious side effects include severe myelosuppression, severe infections, clinically significant bleeding and hemorrhage, infusion related reactions including anaphylaxis, QTc interval prolongation, and embryo-fetal toxicity. Inotuzumab ozogamicin should be prescribed and administered only by health care workers with expertise and experience in cancer chemotherapy and management of its adverse events.

### Hepatotoxicity

In prelicensure clinical trials of inotuzumab ozogamicin, up to half of patients had serum ALT or AST elevations during therapy which were above 5 times the upper limit of normal (ULN) in 2% to 5%. Hyperbilirubinemia was also common during inotuzumab therapy, generally occurring without accompanying ALT or AST elevations. More importantly, a variable proportion of patients (ranging from 2% to 35%) developed clinically apparent sinusoidal obstruction syndrome (SOS) after inotuzumab ozogamicin therapy. The proportion was even higher (15% to 25%) in patients who receive inotuzumab ozogamicin and subsequently underwent hematopoietic cell transplantation (HCT). Symptoms of nausea, right upper quadrant pain, weight gain and abdominal distension (from ascites) arose within 5 to 20 days of the infusion and were followed in some patients by progressive rises in bilirubin, serum aminotransferase and alkaline phosphatase levels. Clinically apparent SOS has a poor prognosis and the mortality rate is as high as 70%, most patients dying of multiorgan failure. Risk factors for developing SOS after inotuzumab therapy include allogenic hematopoietic cell transplantation, use of other antineoplastic agents, and presence of preexisting liver disease. While SOS is the usual cause of clinically apparent liver injury attributable to inotuzumab, cases of cholestatic hepatitis without evidence of sinusoidal cell injury have been described in up to 8% of treated subjects. The clinical features of this injury have not been well characterized. Patients being treated with inotuzumab ozogamicin are often receiving multiple medications and have other reasons for having acute liver injury (sepsis, shock, graft-vs-host disease, or hepatic metastases).

Likelihood score: A (well known cause of clinically apparent liver injury, generally due to sinusoidal obstruction syndrome).

### Mechanism of Liver Injury

The cause of the serum enzyme elevations during inotuzumab ozogamicin therapy is not known, but they are likely due to direct toxicity of the conjugate. The propensity of inotuzumab ozogamicin to cause sinusoidal obstruction syndrome is perhaps due to the fact that the antibody conjugate may be taken up by these cells resulting in their damage and release of cellular apoptotic fragments into sinusoids causing obstruction.

### Outcome and Management

The mild-to-moderate serum aminotransferase elevations that occur during inotuzumab ozogamicin therapy are generally transient and asymptomatic and do not require dose modification or delay in therapy. Elevations above 5 times the upper limit of normal should lead to more careful monitoring and suspension of further infusions, at least until levels return to normal or near normal levels. The product label for inotuzumab ozogamicin has a black boxed warning for the risk of severe sinusoidal obstruction syndrome and recommends monitoring routine liver tests before administering each dose of the antibody-drug conjugate. Management of SOS generally rests on careful attention to fluid balance and treatment of complications. There are no proven means of prevention or treatment of SOS due to inotuzumab ozogamicin, although pretreatment with ursodiol and acute management with defibrotide are often employed. The adverse events profile and hepatotoxicity of inotuzumab ozogamicin are similar to those caused by gemtuzumab ozogamicin, a similar monoclonal antibody-conjugate directed to CD33 that is used to treat refractory or relapsed acute myeloid leukemia.

Drug Class: Antineoplastic Agents; Monoclonal Antibodies

Other Monoclonal Antibody Conjugates: Benlantamab Mafodotin, Brentuximab Vedotin, Enfortumab Vedotin, Gemtuzumab Ozogamicin, Polatuzumab Vedotin, Sacituzumab Govitecan, Tisotumab Vedotin, Trastuzumab Deruxtecan, Trastuzumab Emtansine

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Inotuzumab Ozogamicin – Besponsa®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Inotuzumab+Ozogamicin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Inotuzumab Ozogamicin | 635715-01-4 (https://pubchem.ncbi.nlm.nih.gov/substance/135298753) | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 15 January 2024

Abbreviations: ALL, acute lymphocytic leukemia; AML, acute myeloid leukemia; GvH, graft-vs-host; HCT, hematopoietic cell transplantation; SOS, sinusoidal obstruction syndrome (also known as hepatic veno-occlusive disease).

DeLeve LD. Gemtuzumab ozogamicin. Liver sinusoidal endothelial cells and liver injury. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 142-3. (Review of agents that damage liver sinusoidal cells including gemtuzumab ozogamicin; mentions that CD33 which is present on leukemic blast cells is also present on liver sinusoidal endothelial cells).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2017/761040Orig1s000MultidisciplineR.pdf (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy which mentions that ALT elevations occur in up to 50% of inotuzumab ozogamicin treated subjects and are above 5 times ULN in 2% to 5%, but these abnormalities are generally are self-limited and without symptoms or jaundice, but that SOS occurs in 3% of treated subjects not undergoing HCT and as many as 22% of those with HCT [before or after treatment]).
Rajvanshi P, Shulman HM, Sievers EL, McDonald GB. Hepatic sinusoidal obstruction after gemtuzumab ozogamicin (Mylotarg) therapy. Blood 2002; 99: 2310-4. (Among 23 patients with relapsed, refractory acute myeloid leukemia [AML] treated with gemtuzumab ozogamicin, liver injury suggestive of SOS developed in 11, 7 of whom died of hepatic failure 8-47 days after the infusion). 11895761
Leopold LH, Berger MS, Feingold J. Acute and long-term toxicities associated with gemtuzumab ozogamicin (Mylotarg) therapy of acute myeloid leukemia. Clin Lymphoma 2002; 2 Suppl 1: S29-34. (Review of adverse side effects of gemtuzumab ozogamicin therapy; mentions mild ALT and AST [Grade 1 and 2] elevations in 26% and elevations ≥5 times ULN in 16% and clinically apparent SOS in 2-12% of patients, risk factors for this complication being HCT, concurrent cytotoxic therapies, higher and more frequent doses and underlying liver disease). 11970768
McDonald GB. Management of hepatic sinusoidal obstruction syndrome following treatment with gemtuzumab ozogamicin (Mylotarg). Clin Lymphoma 2002; 2 Suppl 1: S35-9. (Review of management of SOS). 11970769
Kantarjian H, Thomas D, Jorgensen J, Jabbour E, Kebriaei P, Rytting M, York S, et al. Inotuzumab ozogamicin, an anti-CD22-calecheamicin conjugate, for refractory and relapsed acute lymphocytic leukaemia: a phase 2 study. Lancet Oncol 2012; 13: 403-11. (Among 49 patients with refractory or relapsed ALL treated with inotuzumab, 57% had an objective response and adverse events included fever [59%], ALT elevations [57%: all but 1 being less than 5 times ULN], hyperbilirubinemia [26%], hypotension [26%] and SOS in 5 of 22 [23%] who subsequently underwent HCT, 1 case being fatal). 22357140
Wagner-Johnston ND, Goy A, Rodriguez MA, Ehmann WC, Hamlin PA, Radford J, Thieblemont C, et al. A phase 2 study of inotuzumab ozogamicin and rituximab, followed by autologous stem cell transplant in patients with relapsed/refractory diffuse large B-cell lymphoma. Leuk Lymphoma 2015; 56: 2863-9. (Among 63 patients with relapsed or refractory large B cell lymphoma treated with inotuzumab and rituximab, the objective response rate was 29% and adverse events were common including AST elevations in 43%; 4 of 18 patients [22%] who subsequently underwent HCT developed significant hepatotoxicity, 2 with suspected SOS). 25707288
Kantarjian HM, DeAngelo DJ, Stelljes M, Martinelli G, Liedtke M, Stock W, Gökbuget N, et al. Inotuzumab ozogamicin versus standard therapy for acute lymphoblastic leukemia. N Engl J Med 2016; 375: 740-53. (Among 326 patients with refractory or relapsed ALL treated with inotuzumab ozogamicin or standard intensive chemotherapy, complete remissions were more frequent with inotuzumab [81% vs 29%] and medial overall survival was greater [7.7 vs 6.7 months], and while adverse events were frequent in both groups, SOS occurred in 11% [including 2 fatal cases following HCT] with inotuzumab vs 1% with standard therapy). 27292104
Kantarjian HM, Vandendries E, Advani AS. Inotuzumab ozogamicin for acute lymphoblastic leukemia. N Engl J Med 2016; 375: 2100-2101. (Further follow up of patients in a controlled trial [Kantarjian 2016] mentions that 15 of 71 patients [21%] who underwent HCT after receipt of inotuzumab for ALL developed SOS, and that there was no correlation between time after receipt of the agent and frequency of SOS). 27959720
Goy A, Forero A, Wagner-Johnston N, Christopher Ehmann W, Tsai M, Hatake K, Ananthakrishnan R, et al. A phase 2 study of inotuzumab ozogamicin in patients with indolent B-cell non-Hodgkin lymphoma refractory to rituximab alone, rituximab and chemotherapy, or radioimmunotherapy. Br J Haematol 2016; 174: 571-81. (Among 81 patients with refractory non-Hodgkin lymphoma treated with inotuzumab ozogamicin, the objective response rate was 67% and adverse events were common including thrombocytopenia [74%], neutropenia [56%], anemia [15%], ALT elevations [20%: only 1 rising above 5 times ULN] and hyperbilirubinemia [15%]). 27101934
Kantarjian HM, DeAngelo DJ, Advani AS, Stelljes M, Kebriaei P, Cassaday RD, Merchant AA, et al. Hepatic adverse event profile of inotuzumab ozogamicin in adult patients with relapsed or refractory acute lymphoblastic leukaemia: results from the open-label, randomised, phase 3 INO-VATE study. Lancet Haematol 2017; 4: e387-e398. (Secondary analysis of liver related adverse events in a large controlled trial of inotuzumab vs placebo [Kantarjian 2016], with follow up data on all 326 patients enrolled, reported elevations in ALT in 15% vs 13%, AST in 23% vs 11%, Alk P in 13% vs 7%, bilirubin in 21% vs 17% and SOS in 13% [n=22, 5 fatal] vs <1% with SOS occurring without intervening HCT in 5 [3%] vs none). 28687420
Dang NH, Ogura M, Castaigne S, Fayad LE, Jerkeman M, Radford J, Pezzutto A, et al. Randomized, phase 3 trial of inotuzumab ozogamicin plus rituximab versus chemotherapy plus rituximab for relapsed/refractory aggressive B-cell non-Hodgkin lymphoma. Br J Haematol 2018; 182 (4): 583-6. (Among 332 patients with non-Hodgkin lymphoma treated with rituximab combined with inotuzumab ozogamicin or with standard chemotherapy, overall survival was similar in the two groups while adverse events were more frequent with inotuzumab including elevations in ALT [17% vs 8%], Alk P [13% vs 5%], bilirubin [8% vs 2%] and SOS [2% vs none]). 28677896
Lamb YN. Inotuzumab ozogamicin: first global approval. Drugs 2017; 77: 1603-10. (Review of the history of development, mechanism of action, pharmacology, clinical efficacy and safety of inotuzumab ozogamicin shortly after its approval in the US; mentions that cases of SOS were more frequent with inotuzumab than standard therapy [13% vs 1%], some cases arising years after its administration, often after HCT). 28819740
Kantarjian H, Ravandi F, Short NJ, Huang X, Jain N, Sasaki K, Daver N, et al. Inotuzumab ozogamicin in combination with low-intensity chemotherapy for older patients with Philadelphia chromosome-negative acute lymphoblastic leukaemia: a single-arm, phase 2 study. Lancet Oncol 2018; 19: 240-8. (Among 52 elderly patients [60 years or older] with newly diagnosed ALL treated with inotuzumab ozogamicin and low intensity standard chemotherapy, almost all patients had an objective response, and all had hepatic adverse events including SOS in 4 patients [8%], 2 of which were fatal, 1 occurring after HCT). 29352703
Jabbour E, Ravandi F, Kebriaei P, Huang X, Short NJ, Thomas D, Sasaki K, et al. Salvage chemoimmunotherapy with inotuzumab ozogamicin combined with mini-hyper-CVD for patients with relapsed or refractory Philadelphia chromosome-negative acute lymphoblastic leukemia: a phase 2 clinical trial. JAMA Oncol 2018; 4: 230-4. (Among 59 patients with relapsed or refractory ALL treated with inotuzumab and lower dose standard chemotherapy, the overall objective response rate was 78%, while 95% had at least one hepatic adverse event and 9 [15%] developed SOS, all of whom had received HCT either before or after inotuzumab therapy). 28859185
Inotuzumab ozogamicin (Besponsa)--an antibody-drug conjugate for ALL. Med Lett Drugs Ther 2018; 60 (1547): e90-e91. (Concise review of the mechanism of action, clinical efficacy, safety and costs of inotuzumab ozogamicin, shortly after its approval as therapy of refractory or relapsed, B-cell precursor ALL in adults, mentions that SOS occurred in 18 of 79 patients [23%] treated with inotuzumab who subsequently underwent HCT, the mortality rate of which was 28%). 29913470
McDonald GB, Freston JW, Boyer JL, DeLeve LD. Liver complications following treatment of hematologic malignancy with anti-CD22-calicheamicin (inotuzumab ozogamicin). Hepatology. 2019;69:831-844. (Expert analysis of liver injury in two large controlled trials of trastuzumab ozogamicin vs standard care in 628 adults with ALL identified SoS in 1.5% vs none and drug induced liver injury in 8% vs 1%). 30120894
Corbacioglu S, Jabbour EJ, Mohty M. Risk factors for development of and progression of hepatic veno-occlusive disease/sinusoidal obstruction syndrome. Biol Blood Marrow Transplant. 2019;25:1271-1280. (Systematic review of the risk factors for development of SOS after HCT identified gemtuzumab ozogamicin and inotuzumab ozogamicin as having hazard risk odds ratios of 20 and 22). 30797942
Kantarjian HM, DeAngelo DJ, Stelljes M, Liedtke M, Stock W, Gökbuget N, O'Brien SM, et al. Inotuzumab ozogamicin versus standard of care in relapsed or refractory acute lymphoblastic leukemia: final report and long-term survival follow-up from the randomized, phase 3 INO-VATE study. Cancer. 2019;125: 2474-2487. (Among 326 adults with refractory or relapsed ALL treated with inotuzumab ozogamicin or standard chemotherapy and followed for 2 years or more, the complete remission rate was 74% vs 31%, and the 2-year overall survival rate was 23% vs 10%, although SOS occurred in 14% vs 2%). 30920645
Agrawal V, Pourhassan H, Tsai NC, Ngo D, Koller P, Malki MMA, Salhotra A, et al. Post-transplantation sinusoidal obstruction syndrome in adult patients with B cell acute lymphoblastic leukemia treated with pretransplantation inotuzumab. Transplant Cell Ther. 2023;29:314-320. (Among 47 adults with refractory or relapsed ALL who received inotuzumab ozogamicin and subsequently underwent HCT, 12 [26%] developed SOS which was severe in 9 and fatal in 4). 36682470
Lee J, Yoon JH, Kwag D, Lee JH, Kim TY, Min GJ, Park SS, et al. Hepatic venoocclusive disease/sinusoidal obstruction syndrome with normal portal vein flow mimicking aggravated chronic hepatic GVHD following inotuzumab ozogamicin salvage therapy: a case report of pathologic-radiologic discrepancy. Ther Adv Hematol. 2021;12:20406207211066176. (49 year old woman with relapse of ALL 2 years after a successful HCT and with chronic graft-vs-host [GvH] disease was treated with inotuzumab ozogamicin and developed progressive hepatic failure that led to a liver transplant, the explant showing SOS rather than GvH disease). 34987745
Sabatino D, Henneman A, Ahmad S, Jou E, Goldberg B. Evaluation of the efficacy of ursodiol for prevention of hepatotoxicity in patients receiving gemtuzumab ozogamicin and inotuzumab ozogamicin. J Oncol Pharm Pract. 2023;29:840-845. (In a retrospective analysis of patients who received gemtuzumab or inotuzumab ozogamicin with [n=14] or without ursodiol [n=35] prophylaxis, the rate of SOS was less with ursodiol [14% vs 43%], but after controlling for risk factors the difference was not statistically significant). 35293248
Fischer D, Toenges R, Kiil K, Michalik S, Thalhammer A, Bug G, Gökbuget N, Lang F. Liver failure after treatment with inotuzumab and polychemotherapy including PEG-asparaginase in a patient with relapsed Philadelphia chromosome-negative acute lymphoblastic leukemia. Ann Hematol. 2024;103(2):489-498. (58 year old woman with relapsed ALL after HCT was treated with inotuzumab ozogamicin followed by methotrexate and pegaspargase and developed fatal acute liver failure 2 weeks later, autopsy showing steatosis and cholestasis typical of asparaginase induced injury, but no evidence of SOS). 37999763
Sun C, Yang X, Tang L, Chen J. A pharmacovigilance study on drug-induced liver injury associated with antibody-drug conjugates (ADCs) based on the food and drug administration adverse event reporting system. Expert Opin Drug Saf. 2023:1-12. (Analysis of the FDA reporting system [FAERS] for cases of drug induced liver injury submitted between 2004 and 2022, found 17,784 reports, 504 [3%] attributed to antibody-drug conjugates, 202 from the US, the implicated agents being gemtuzumab ozogamicin [n=98], brentuximab vedotin [n=37], trastuzumab emtansine [n=25], enfortumab vedotin [n=16], inotuzumab ozogamicin [n=15], transtuzumab deruxtecan [n=8], and polatuzumab vedotin [3]). 37898875

## OTHER REFERENCE LINKS

Recent References on Inotuzumab Ozogamicin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Inotuzumab+Ozogamicin/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Inotuzumab Ozogamicin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Inotuzumab+Ozogamicin)